# Rufinamide

## OVERVIEW

### Introduction

Rufinamide is a unique anticonvulsant that is used in combination with other agents as therapy of severe forms of seizure disorders. Rufinamide therapy is associated with a low rate of transient serum enzyme elevations and with rare instances of clinically apparent liver injury.

### Background

Rufinamide (roo fin' a mide) is a unique triazole derivative that appears to act by prolonging the inactivation of voltage gated sodium channels in the central nervous system, thus slowing the rate of neurotransmission and decreasing rapid, repetitive neuronal firing. Rufinamide was approved for use in the United States in 2008 as an anticonvulsant to be used in combination with other agents (adjunctive therapy) for Lennox-Gastaut syndrome in adults and children 1 year of age and older. Rufinamide is available in tablets of 200 and 400 mg and as an oral suspension of 40 mg/mL under the brand name Banzel. The typical dose in children is 10 mg/kg in two divided doses daily, which can be increased to a maximum of 45 mg/kg daily. In adults the dose is 400 to 800 mg daily in two divided doses, which can be increased to a maximum of 3200 mg daily. Side effects may include headache, dizziness, somnolence, ataxia, tremor, fatigue, nausea and rash. Rare, but potentially severe adverse events include depression, suicidal thoughts and behavior, mood changes and hypersensitivity reactions including Stevens Johnson syndrome.

### Hepatotoxicity

In prelicensure clinical trials, addition of rufinamide to standard anticonvulsant therapy was reported to be associated with only rare elevations in ALT above 3 times the upper limit of normal (ULN). Rufinamide was not linked to instances of clinically apparent liver injury, but a pooled analysis of more than 200 children mentioned that two patients needed to discontinue therapy early because of liver related adverse events, one of which was described as “toxic hepatitis”. Since approval, there have been no reports of clinically apparent liver injury associated with rufinamide use, but it has had limited use in epilepsy. Rufinamide has been linked to instances of severe cutaneous reactions, including Stevens Johnson syndrome which often has some degree of associated liver injury. Thus, rufinamide may cause liver injury, but it is rare.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

Rufinamide is metabolized by the liver, largely by CYP 2C19, but has not been reported to have significant drug interactions. The possible mechanism of hepatic injury from rufinamide is not known, but may relate to a toxic or immunogenic metabolite.

### Outcome and Management

There is no information on the possible cross sensitivity to hepatotoxicity between rufinamide and other anticonvulsants, but its structure would not suggest that there would not be shared sensitivity with the more commonly used medications for seizures.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Rufinamide – Banzel®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Rufinamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Rufinamide | 106308-44-5 | C10-H8-F2-N4-O | Rufinamide chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2018

Kaplowitz Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999 before the availability of rufinamide).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-42. (Review of anticonvulsant induced liver injury; rufinamide is not discussed).
McNamara JO. Rufinamide. Pharmacotherapy of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, p. 602. (Textbook of pharmacology and therapeutics).
Pålhagen S, Canger R, Henriksen O, van Parys JA, Rivière ME, Karolchyk MA. Rufinamide: a double-blind, placebo-controlled proof of principle trial in patients with epilepsy. Epilepsy Res. 2001; 43: 115-24. (Among 50 patients with seizures treated with rising doses of rufinamide or placebo for 28 days, side effects included fatigue, headache, tremor, ataxia and dizziness, but there were no “clinically relevant” changes in laboratory test results). 11164700
Glauser T, Kluger G, Sachdeo R, Krauss G, Perdomo C, Arroyo S. Rufinamide for generalized seizures associated with Lennox-Gastaut syndrome. Neurology 2008; 70: 1950-8. (Among 138 patients with Lennox-Gastaut syndrome [ages 4 to 30 years] treated with rufinamide or placebo for 12 weeks, rufinamide was not associated with “clinically significant changes in … laboratory tests”). 18401024
Wisniewski CS. Rufinamide: a new antiepileptic medication for the treatment of seizures associated with Lennox-Gastaut syndrome. Ann Pharmacother 2010; 44: 658-67. (Review of the efficacy and safety of rufinamide; no discussion of ALT elevations or hepatotoxicity). 20233912
Rufinamide (Banzel) for epilepsy. Med Lett Drugs Ther 2009; 51 (1307): 18-20. (Concise review of the pharmacology, efficacy, adverse events, drug interactions and costs of rufinamide shortly after its approval in the US mentions common side effects, but not ALT elevations or hepatotoxicity). 19265777
Brodie MJ, Rosenfeld WE, Vazquez B, Sachdeo R, Perdomo C, Mann A, Arroyo S. Rufinamide for the adjunctive treatment of partial seizures in adults and adolescents: a randomized placebo-controlled trial. Epilepsia 2009; 50: 1899-909. (Among 313 patients with partial onset seizures treated with rufinamide or placebo for 13 weeks, common side effects included dizziness, headache, nausea, somnolence and diplopia; no mention of ALT elevations or hepatotoxicity). 19490053
Wheless JW, Conry J, Krauss G, Mann A, LoPresti A, Narurkar M. Safety and tolerability of rufinamide in children with epilepsy: a pooled analysis of 7 clinical studies. J Child Neurol 2009; 24: 1520-5. (In a pooled analysis of 7 clinical studies including 212 rufinamide and 197 placebo recipients, changes in laboratory values “were generally clinically insignificant”, however, there were two discontinuations for liver related adverse events, one for “toxic hepatitis” resolving within 17 days and one for serum enzyme elevations resolving within 4 days; 5 children developed a hypersensitivity reaction [fever and rash within the first 4 weeks of treatment], but hepatic involvement was not mentioned). 19955344
Elger CE, Stefan H, Mann A, Narurkar M, Sun Y, Perdomo C. A 24-week multicenter, randomized, double-blind, parallel-group, dose-ranging study of rufinamide in adults and adolescents with inadequately controlled partial seizures. Epilepsy Res 2010; 88: 255-63. (Among 647 patients with poorly controlled partial onset seizures treated with adjunctive rufinamide [200, 400, 800 or 1600 mg daily] or placebo for 24 weeks, there were no liver related serious adverse events or early discontinuation; no mention of ALT elevations). 20061123
Biton V, Krauss G, Vasquez-Santana B, Bibbiani F, Mann A, Perdomo C, Narurkar M. A randomized, double-blind, placebo-controlled, parallel-group study of rufinamide as adjunctive therapy for refractory partial-onset seizures. Epilepsia 2011; 52: 234-42. (Among 357 patients treated with adjunctive rufinamide or placebo for 3 months, there were no significant changes in laboratory values or discontinuations for liver related adverse events). 20887365
Moavero R, Cusmai R, Specchio N, Fusco L, Capuano A, Curatolo P, Vigevano F. Rufinamide efficacy and safety as adjunctive treatment in children with focal drug resistant epilepsy: the first Italian prospective study. Epilepsy Res 2012; 102: 94-9. (Among 70 children with focal seizures treated with add on rufinamide for up to 12 months, the authors found no laboratory test abnormalities). 22677424
Gaitatzis A, Sander JW. The long-term safety of antiepileptic drugs. CNS Drugs 2013; 27: 435-55. (Review of the long term safety and adverse event profile of anticonvulsants mentions that valproate and felbamate can cause liver failure, but does no mention hepatotoxicity of other antiepileptics). 23673774
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of indications and side effects of anticonvulsants; rufinamide is approved as add on therapy of Lennox-Gastaut syndrome in children and adults; discussion of adverse effects does not mention hepatotoxicity, but mentions that rufinamide is a mild inducer of CYP 3A4). 23348233
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to rufinamide). 23419359
Grosso S, Coppola G, Dontin SD, Gobbi G, Pruna D, Accorsi P, Verrotti A, et al. Efficacy and safety of rufinamide in children under four years of age with drug-resistant epilepsies. Eur J Paediatr Neurol 2014; 18: 641-5. (Among 40 children with refractory epilepsy receiving add on rufinamide for an average of 12 months, “biochemical tests resulted normal in all patients”). 24912730
Thome-Souza S, Kadish NE, Ramgopal S, Sánchez Fernández I, Bergin AM, Bolton J, Harini C, et al. Safety and retention rate of rufinamide in 300 patients: a single pediatric epilepsy center experience. Epilepsia 2014; 55: 1235-44. (Among 300 patients [ages 1 to 30 years] with refractory epilepsy receiving add on rufinamide for an average of 9 months, 110 [37%] discontinued therapy early, 47 [16%] for adverse events, but none for liver related side effects; no mention of ALT elevations or hepatotoxicity). 25070475
Ohtsuka Y, Yoshinaga H, Shirasaka Y, Takayama R, Takano H, Iyoda K. Rufinamide as an adjunctive therapy for Lennox-Gastaut syndrome: a randomized double-blind placebo-controlled trial in Japan. Epilepsy Res 2014; 108: 1627-36. (Among 59 Japanese patients with Lennox-Gastaut syndrome receiving adjunctive rufinamide for partial onset seizures for 12 weeks, none had a serious adverse event or discontinuation for an adverse event; no mention of ALT elevations or hepatotoxicity). 25219353
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsants, but none to rufinamide). 25754159
McMurray R, Striano P. Treatment of Adults with Lennox-Gastaut Syndrome: Further analysis of efficacy and safety/tolerability of rufinamide. Neurol Ther 2016; 5: 35-43. (Among 31 adults with seizures treated with rufinamide or placebo for 84 days, adverse events were mild-to-moderate in severity and there were no "clinically significant changes" in laboratory tests). 26861566
Ohtsuka Y, Yoshinaga H, Shirasaka Y, Takayama R, Takano H, Iyoda K. Long-term safety and seizure outcome in Japanese patients with Lennox-Gastaut syndrome receiving adjunctive rufinamide therapy: An open-label study following a randomized clinical trial. Epilepsy Res 2016; 121: 1-7. (Among 54 patients with Lennox-Gastaut syndrome treated for at least 52 weeks in a open label extension trial, seizure control was maintained and side effects included somnolence, anorexia and weight loss; no mention of ALT elevations or hepatotoxicity). 26827266
Nikanorova M, Brandt C, Auvin S, McMurray R. Real-world data on rufinamide treatment in patients with Lennox-Gastaut syndrome: Results from a European noninterventional registry study. Epilepsy Behav 2017; 76: 63-70. (Among 64 patients followed in a prospective registry who started rufinamide treatment, most adverse events were mild-to-moderate in severity and included somnolence [8%], decreased appetite [6%] and fatigue [5%]; no mention of ALT elevations or hepatotoxicity). 28927712

## OTHER REFERENCE LINKS

1. Recent References on Rufinamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Rufinamide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Rufinamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Rufinamide)